# Galcanezumab

## OVERVIEW

### Introduction

Galcanezumab is a monoclonal antibody to the calcitonin gene related peptide which is used for prevention of migraine in patients with episodic or chronic migraine headaches. Galcanezumab has not been associated with serum enzyme elevations during therapy nor has it been implicated in cases of clinically apparent drug induced liver injury with jaundice.

### Background

Galcanezumab (gal" ka nez' ue mab) is a recombinant, humanized monoclonal antibody to the calcitonin gene related peptide (CGRP), a neuropeptide which plays an important role in migraine headaches. CGRP is found throughout the central and peripheral nervous systems and has potent vasodilator and pain-signaling activities. Circulating levels of CGRP are elevated in patients with migraines, and the efficacy of migraine therapies (serotonin receptor agonists, ergot alkaloids) is associated with lowering of CGRP levels. Galcanezumab is a CGRP antagonist and blocks the neuropeptide from binding to its receptor and the subsequent downstream activation of the intracellular signaling pathways. Galcanezumab was approved for use in the United States in 2018 as a means of prevention of migraine headaches and was one of three CGRP antagonists approved in 2018 for this indication (the others being erenumab and fremanezumab). Galcanezumab is available in solution in single use prefilled syringes or pens of 120 mg under the brand name Emgality. The recommended initial dose is 240 mg subcutaneously followed by 120 mg once monthly. Galcanezumab is not effective as therapy of acute migraine, and it lowers the frequency but typically does not abolish all episodes of chronic migraine headaches. Side effects of galcanezumab are uncommon but can include injection site and hypersensitivity reactions. Galcanezumab has not been associated with significant numbers of severe adverse events, however it has had limited general use and the effects of long term suppression of CGRP signaling are unknown, but could theoretically increase the rate of serious cardiovascular or cerebrovascular ischemic events.

### Hepatotoxicity

In large clinical trials, galcanezumab was associated with isolated, rare instances of elevations in serum aminotransferase levels during therapy (<1%) and rates of most adverse reactions, except for injection site reactions, were similar to those in patients who received placebo. There have been no published reports of clinically apparent acute liver injury attributed to galcanezumab therapy. Thus, significant liver injury from galcanezumab must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Galcanezumab is a humanized monoclonal antibody and is unlikely to be inherently hepatotoxic. While most recombinant proteins are metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Galcanezumab has minimal effect on hepatic microsomal enzyme activity and has not been linked to adverse drug-drug interactions.

Drug Class: Migraine Headache Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Galcanezumab – Emgality®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ergot+Alkaloids)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Galcanezumab | 1578199-75-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Abbreviations: CGRP, calcitonin gene related protein.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of monoclonal immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; galcanezumab is not discussed).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Skljarevski V, Matharu M, Millen BA, Ossipov MH, Kim BK, Yang JY. Efficacy and safety of galcanezumab for the prevention of episodic migraine: Results of the EVOLVE-2 Phase 3 randomized controlled clinical trial. Cephalalgia 2018; 38: 1442-54. (Among 915 patients with episodic migraine treated with galcanezumab [120 or 240 mg] or placebo injections monthly for 6 months, headache days decreased more with active drug than placebo [-4.3 and -4.2 vs -2.3 days per month] and adverse event rates were similar in all 3 groups except for injection site reactions; one patient on the highest dose of galcanezumab discontinued early because of “hepatic enzyme” elevations). 29848108
Edvinsson L. The CGRP pathway in migraine as a viable target for therapies. Headache 2018; 58 Suppl 1: 33-47. (Review of the calcitonin gene related peptide and its receptor including their relationship to migraine headaches and development of small molecular inhibitors and monoclonal antibody therapies based upon their inhibition). 29697153
Tepper SJ. History and review of anti-calcitonin gene-related peptide (CGRP) therapies: from translational research to treatment. Headache 2018; 58 Suppl 3: 238-75. (Review of the role of CGRP in pathogenesis of migraine headaches and the development of small molecules and monoclonal antibody antagonists of CGRP actions). 30242830
Lamb YN. Galcanezumab: first global approval. Drugs 2018; 78: 1769-75. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of galcanezumab shortly after its approval for use in the US; mentions that injection site reactions were the most frequent adverse effect [18%]; no mention of ALT elevations or hepatotoxicity). 30378008
Detke HC, Goadsby PJ, Wang S, Friedman DI, Selzler KJ, Aurora SK. Galcanezumab in chronic migraine: The randomized, double-blind, placebo-controlled REGAIN study. Neurology 2018 Nov 16. [Epub ahead of print] (Among 1133 patients with chronic migraine treated with galcanezumab [120 or 240 mg] or placebo injections monthly, headache days decreased more with active drug than placebo [-4.6 and -4.8 vs -2.7 days per month] while adverse event rates were similar except for injection site reactions [3% and 5% vs 2%], and 2 subjects “had a treatment-emergent abnormal hepatic enzyme”, 1 on galcanezumab and 1 on placebo). 30446596
Camporeale A, Kudrow D, Sides R, Wang S, Van Dycke A, Selzler KJ, Stauffer VL. A phase 3, long-term, open-label safety study of galcanezumab in patients with migraine. BMC Neurol 2018; 18: 188. (Among 270 adults with episodic or chronic migraine treated with galcanezumab [120 or 240 mg] monthly for one year, headache days decreased with both doses [-5.6 and -6.5 days per month] and liver test abnormalities arose in only 4 patients, all of which were transient resolving without discontinuation). 30413151
Fremanezumab (Ajovy) and galcanezumab (Emgality) for migraine prevention. Med Lett Drugs Ther 2018; 60 (1559): 177-80. (Concise review of the mechanism of action, clinical efficacy, safety and costs of fremanezumab and galcanezumab shortly after their approval for prevention of migraine; does not mention ALT elevations or hepatotoxicity). 30681655

## OTHER REFERENCE LINKS

1. Recent References on Galcanezumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Galcanezumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Galcanezumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Galcanezumab)